# Nifurtimox

## OVERVIEW

### Introduction

Nifurtimox is a nitrofuran antimicrobial agent used to treat Chagas disease (American trypanosomiasis), a chronic protozoal infection due to Trypanosoma cruzi that can lead to severe disability and death from gastrointestinal and cardiac disease. Nifurtimox is rarely associated with serum aminotransferase elevations during therapy and has not been linked to cases of clinically apparent liver injury.

### Background

Nifurtimox (nye fure’ ti mox) is a nitrofuran antimicrobial agent used in the therapy of American trypanosomiasis, Chagas disease, a chronic infection with Trypanosoma cruzi. Chagas disease is a vector-borne disease transmitted by the bite of the triatomine bugs. The disease is endemic in Central and South America and cases in the United States are found predominantly in immigrants from endemic areas of the world. Chagas disease causes a mild and often asymptomatic acute infection that can be accompanied by fever, lymphadenopathy, hepatosplenomegaly, and rash. If untreated, acute infection invariably leads to a chronic infection which is asymptomatic for years or decades (indeterminate chronic infection) but progresses over years and decades to clinically apparent cardiac or gastrointestinal disease or both in up to 30% of patients. Treatment of Chagas disease focuses largely on the indeterminate chronic phase of illness with the goal of preventing the long term cardiac and gastrointestinal complications. Two medications are currently approved in the United States for Chagas disease: benznidazole and nifurtimox, and the current indications are limited to children. Nifurtimox is a prodrug that is converted to toxic radicals and DNA-damaging, reactive oxygen species by nitroreductases that are found in the mitochondria of parasites but are absent or present in low levels in humans. Nifurtimox has been shown to result in clearance of parasitemia and apparent resolution of infection in the majority of patients with Chagas disease and was approved in the United States in children from birth to age 18 years in 2021. Nifurtimox is available in tablets of 30 and 120 mg under the brand name Lampit. The currently recommended dose in children weighing 2.5 to 40 kg is 10 to 20 mg/kg per day and for those weighing 41 kg or more is 8 to 10 mg/kg per day given in 3 divided doses for 60 days. Adverse events are common and are a reason for early discontinuation of therapy in up to 10% of children. Common adverse events include anorexia, nausea and vomiting, abdominal pain, headache, dizziness, fatigue, insomnia, anxiety, rash, and neuropathy. Rare but potentially severe adverse events include embryo-fetal toxicity, hypersensitivity reactions, precipitation of acute porphyria, psychosis and carcinogenesis.

### Hepatotoxicity

In multiple prospective controlled trials, nifurtimox therapy was not associated with elevations in aminotransferase or bilirubin levels or with instances of clinically apparent liver injury. Since approval of nifurtimox for American trypanosomiasis, there have been no individual reports of liver injury associated with its use.

Likelihood score: E (unlikely cause of clinically apparent liver injury when given in the recommended regimens for Chagas disease).

### Mechanism of Injury

The mechanism by which nifurtimox might cause liver injury is unknown. Nifurtimox is a prodrug that is activated to an reactive metabolite by parasites but not in human cells. Nifurtimox has many diverse adverse side effects, which often limit the dose and duration of therapy and might overshadow mild degrees of liver injury due to generation of low levels of toxic metabolites in hepatocytes.

### Outcome and Management

Nifurtimox therapy has not been associated with the liver injury reported. It is unknown whether there is cross sensitivity with other benzimidazoles (such as mebendazole), but there probably is and switching to another class of anthelmintic agents is appropriate if therapy is still needed.

Drug Class: Antiinfective Agents, Trypanosomiasis Agents

Other Trypanosomiasis Agents: Benznidazole, Fexinidazole

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nifurtimox – Lampit®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nifurtimox)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Nifurtimox | 23256-30-6 | C10-H13-N3-O5-S

## ANNOTATED BIBLIOGRAPHY

References updated: 18 July 2023

Abbreviations used: NECT, nifurtimox and eflornithine combination therapy.

Zimmerman HJ. Antihelminthics. Hepatic injury from antimicrobial agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 626-8. (Expert review of hepatotoxicity of drugs for parasite infections written in 1999, before the availability of drugs for trypanosomiasis).
Wetzel DM, Phillips MA. Chemotherapy of protozoal infections: amebiasis, giardiasis, trichomoniasis, trypanosomiasis, Leishmaniasis, and other protozoal infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 987-99. (Textbook of pharmacology and therapeutics).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin American published between 1996 and 2012, none were attributed for agents used to treat trypanosomiasis including Chagas disease). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to medications for parasitic diseases). 25754159
Forsyth CJ, Hernandez S, Olmedo W, Abuhamidah A, Traina MI, Sanchez DR, Soverow J, et al. Safety profile of nifurtimox for treatment of Chagas disease in the United States. Clin Infect Dis. 2016;63:1056-1062. (Among 53 adult U.S. immigrants from Latin America with chronic indeterminate Chagas disease treated with nifurtimox [8 to 10 mg/kg daily for 12 weeks] adverse events were frequent, mostly mild and arising during the first 2 weeks of therapy, leading to early discontinuation in 21% of patients, and including anorexia [79%], nausea [76%], headache [60%], amnesia [59%], fatigue [42%] anxiety, insomnia, and rash; no mention of ALT elevations or hepatotoxicity). 27432838
Mesu VKBK, Kalonji WM, Bardonneau C, Mordt OV, Blesson S, Simon F, Delhomme S, et al. Oral fexinidazole for late-stage African Trypanosoma brucei gambiense trypanosomiasis: a pivotal multicentre, randomised, non-inferiority trial. Lancet. 2018;391:144-154. (Among 394 patients [ages 15 years or above] with late stage African trypanosomiasis treated with fexinidazole or NECT therapy for 20 days, success rates at 18 months after enrollment were 91% vs 98% [a non-inferior result], and adverse events rates were similar [94% vs 92%] including severe adverse events [12% vs 10%]; and while ALT elevations and hepatotoxicity were not specifically mentioned, “There were no clinically significant changes in any…laboratory values over the duration of treatment”). 29113731
Villar JC, Herrera VM, Pérez Carreño JG, Váquiro Herrera E, Castellanos Domínguez YZ, Vásquez SM, Cucunubá ZM, et al. Nifurtimox versus benznidazole or placebo for asymptomatic Trypanosoma cruzi infection (Equivalence of Usual Interventions for Trypanosomiasis - EQUITY): study protocol for a randomised controlled trial. Trials. 2019;20:431. (Protocol for a prospective randomized placebo controlled trial of benznidazole vs nifurtimox [for 60 days at full doses or 120 days at half doses] using PCR negativity on 3 occasions 12-18 months after enrollment as the primary endpoint). 31307503
Jackson Y, Wyssa B, Chappuis F. Tolerance to nifurtimox and benznidazole in adult patients with chronic Chagas' disease. J Antimicrob Chemother. 2020;75:690-696. (Among 176 patients with chronic indeterminate Chagas disease treated with either benznidazole or nifurtimox at traditional doses for 60 days between 2008 and 2016 at a single Swiss medical center, adverse events were frequent with both regimens [90%], commonly pruritus [37% vs 20%], rash [29% vs 14%], anorexia [22% vs 74%], nausea [36% vs 55%], abdominal pain [22% vs 39%], headache [40% vs 71%], neuropathy [21% vs 5%], vertigo [7% vs 27%], insomnia [26% vs 50%], psychosis [1% vs 1%], fatigue [44% vs 69%], fever [0% vs 14%], arthralgia [4% vs 26%], with only 63% of patients completing therapy; no mention of ALT elevations or hepatotoxicity). 31754690
Berenstein AJ, Falk N, Moscatelli G, Moroni S, González N, Garcia-Bournissen F, Ballering G, et al. Adverse events associated with nifurtimox treatment for Chagas disease in children and adults. Antimicrob Agents Chemother. 2021;65:e01135-20. (Among 320 patients with Chagas disease [215 children, 105 adults] treated with nifurtimox in a single Argentinian medical center between 1980 and 2019, adverse events were common [40%], were more frequent in adults than children [61% vs 29%] and included anorexia, weight loss, irritability, headache, nausea, vomiting, and rash leading to early discontinuation in 10% of patients; no mention of ALT elevations or hepatotoxicity). 33168612
Altcheh J, Castro L, Dib JC, Grossmann U, Huang E, Moscatelli G, Pinto Rocha JJ, et al.; CHICO Study Group. Prospective, historically controlled study to evaluate the efficacy and safety of a new paediatric formulation of nifurtimox in children aged 0 to 17 years with Chagas disease one year after treatment (CHICO). PLoS Negl Trop Dis. 2021;15:e0008912. (Among 330 children with Chagas disease treated with nifurtimox for 30 or 60 days, serological responses were more frequent with longer therapy [33% vs 19%], while PCR positivity fell from 52% initially to 1% at one year in both groups; adverse event rates were similar [28% vs 26%]; no mention of ALT elevations or hepatotoxicity). 33412557
Falk N, Berenstein AJ, Moscatelli G, Moroni S, González N, Ballering G, Freilij H, et al. Effectiveness of nifurtimox in the treatment of Chagas disease: a long-term retrospective cohort study in children and adults. Antimicrob Agents Chemother. 2022;66:e0202121. (Among 289 patients with Chagas disease treated with nifurtimox at a single medical center in Argentina, all except one cleared parasitemia by the end of treatment, 35% had seroconversion and 58% seroreduction). 35416710
Abbott A, Montgomery SP, Chancey RJ. Characteristics and adverse events of patients for whom nifurtimox was released through CDC-sponsored investigational new drug program for treatment of Chagas disease - United States, 2001-2021. MMWR Morb Mortal Wkly Rep. 2022;71:371-374. (Among 336 patients with Chagas disease who were treated with nifurtimox under a CDC approved Investigation New Drug treatment protocol between 2001-2021, ages ranged from 1 to 78 years, 93% were Hispanic, and 91% had at least one adverse event, 21% being reported as severe, most commonly nausea, anorexia, weight loss, headache, and abdominal pain, but only one case of elevated ALT levels and no instance of severe hepatic adverse events). 35271563
Altcheh J, Sgierra V, Ramirez T, Pinto Rocha JJ, Grossmann U, Huang E, Moscatelli G, et al. Efficacy and Safety of Nifurtimox in Pediatric Patients with Chagas Disease: Results at 4-Year Follow-Up in a Prospective, Historically Controlled Study (CHICO SECURE). Antimicrob Agents Chemother. 2023;67:e0119322. (Four year follow up on 295 children treated with nifurtimox in the CHICO study [Altcheh 2021], all of whom remained free of signs or symptoms of cardiomyopathy and more than 90% remained T cruzi PCR negative while there were no new adverse events). 36975790
Hochberg NS, Montgomery SP. Chagas Disease. Ann Intern Med. 2023;176:ITC17-ITC32. (Review of the risk factors and causes, clinical features and natural history, epidemiology, pathogenesis, diagnosis, management and treatment of American trypanosomiasis known as Chagas disease after the scientist who first identified the causative parasite). 36780647
Torrico F, Gascón J, Ortiz L, Pinto J, Rojas G, Palacios A, Barreira F, et al. A phase 2, randomized, multicenter, placebo-controlled, proof-of-concept trial of oral fexinidazole in adults with chronic indeterminate Chagas Disease. Clin Infect Dis. 2023;76:e1186-e1194. (Among 47 adults with chronic indeterminate Chagas disease treated with 1 of 6 regimens of fexinidazole given orally for 2, 4 or 8 weeks or placebo [n=7], rapid sustained clearance of parasitemia was achieved in all subjects but adverse events included delayed onset neutropenia [20%] and serum aminotransferase elevations [40% above 3 times ULN], which often arose after therapy was stopped and persisted beyond 3 months in 23% but were asymptomatic and ultimately resolved in all). 35925555

## OTHER REFERENCE LINKS

1 Recent References on Nifurtimox: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Nifurtimox/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Nifurtimox: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nifurtimox)